# Gemifloxacin

## OVERVIEW

### Introduction

Gemifloxacin is a fourth generation, oral fluoroquinolone antibiotic used in the therapy of mild-to-moderate respiratory tract infections caused by susceptible organisms. Gemifloxacin has been linked to rare instances of acute liver injury.

### Background

Gemifloxacin is an oral, fourth generation fluoroquinolone that is used to treat mild-to-moderate respiratory tract infections. Like other fluoroquinolones, gemifloxacin is active against a wide range of aerobic gram-positive and gram-negative organisms and is believed to act by inhibition of bacterial DNA gyrase and topoisomerase IV that are required for synthesis of bacterial mRNAs (transcription) and DNA replication. In contrast, DNA gyrases are not present in human [and other eukarotic] cells and the equivalent topoisomerases are not sensitive to fluoroquinolone inhibition. Gemifloxacin was approved for use in the United States in 2003 and has not been as commonly used as other fluoroquinolones such as ciprofloxacin and levofloxacin. Current indications are limited to acute exacerbations of chronic bronchitis and community acquired pneumonia. Gemifloxacin is available under the commercial name Factive in 320 mg tablets. The recommended dose is 320 mg once daily for 5 to 7 days. Common side effects include diarrhea, nausea, abdominal pain, headaches, skin rash and allergic reactions. The less common but more severe side effects of the fluoroquinolones include prolongation of the QT interval, seizures, hallucinations, tendon rupture, severe hypersensitivity reactions, Stevens Johnson syndrome, angioedema and photosensitivity.

### Hepatotoxicity

Gemifloxacin (jem" i flox' a sin), like other fluoroquinolones, is associated with a low rate (1% to 7%) of serum enzyme elevations during therapy, although this rate may be slightly higher than occurs with placebo or comparative agents. These abnormalities are generally mild, asymptomatic and transient, resolving even with continuation of therapy. Too few cases of hepatotoxicity due to gemifloxacin have been reported to provide a reliable description of its clinical features and course. However, the liver injury due to the fluoroquinolones appears to be a class effect, and gemifloxacin injury appears to share these characteristics. It is a far less common cause of liver injury than ciprofloxacin, levofloxacin or moxifloxacin, but cases have been reported. In general, fluoroquinone hepatotoxicity is marked by a short time to onset (a few days to 3 weeks); often presenting abruptly with marked nausea, fatigue, abdominal pain and jaundice. The pattern of serum enzyme elevations can be either hepatocellular or cholestatic, and cases with the shorter times to onset are usually more hepatocellular with markedly elevated ALT levels, and occasionally, with rapid worsening of prothrombin time and signs of hepatic failure. The onset of illness may occur a few days after the medication is stopped. Many (but not all) cases have had allergic manifestations with fever, rash and eosinophilia. Autoantibodies are usually not present.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of fluoroquinolone hepatotoxicity is suspected to be hypersensitivity. Rechallenge leads to recurrence and should be avoided.

### Outcome and Management

While few cases of clinically apparent liver injury due to gemifloxacin have been reported, such injury does occur with other fluoroquinolones, even with brief periods of treatment (2 to 5 days). The severity of injury ranges from mild, asymptomatic and transient serum enzyme elevations to a mild, prolonged cholestatic hepatitis, to self-limited acute hepatocellular jaundice and even to acute liver failure. Cross reactivity of the hepatic injury between different fluoroquinolones has been demonstrated in a small number of cases, but should be assumed based upon the similarity of clinical patterns of injury and latency.

Drug Class: Antiinfective Agents

Other Drugs in the Subclass, Fluoroquinolones: Ciprofloxacin, Delafloxacin, Levofloxacin, Moxifloxacin, Norfloxacin, Ofloxacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gemifloxacin – Factive®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Gemifloxacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Gemifloxacin | 175463-14-6 | C18-H20-F-N5-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 10 March 2020

Zimmerman HJ. Quinolones. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 603. (Expert review of hepatotoxicity published in 1999, before the availability of gemifloxacin, mentions that cinoxacin, nalidixic acid, ciprofloxacin, norfloxacin, enoxacin, and ofloxacin are associated with minor serum enzyme elevations during therapy and with rare instances of clinically apparent liver injury; gemifloxacin is not discussed).
Moseley RH. Fluoroquinolones. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 468. (Review of hepatotoxicity of fluoroquinolones mentions that, although rare, hepatocellular and cholestatic forms of fluoroquinolone associated clinically apparent liver injury have been reported including cases of ductopenia, acute liver failure and death; gemifloxacin is not specifically discussed).
MacDougall C. The quinolones. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1015-8. (Textbook of pharmacology and therapeutics).
Bertino J, Fish D. (2000). The safety profile of the fluoroquinolones. Clin Ther. (Systematic review of literature on safety of fluoroquinolones; most common side effects are gastrointestinal complaints [1-8%]; rare side effects include anaphylaxis, prolongation of QTc interval, tendon rupture and CNS toxicity; trovafloxacin has been linked to several cases of acute liver failure; no discussion of gemifloxacin).
File TM, Schlemmer B, Garau J, Cupo M, Young C. (2001). 049 Clinical Study Group. Efficacy and safety of gemifloxacin in the treatment of community-acquired pneumonia: a randomized, double-blind comparison with trovafloxacin. J Antimicrob Chemother. (Controlled trial comparing oral gemifloxacin vs trovafloxacin in 571 patients with community acquired pneumonia found similar rates of response and side effects; ALT or AST elevations occurred in 2.1% of trovafloxacin treated [peak ALT 184 U/L] vs 0.3% of gemifloxacin treated [peak ALT 139 U/L], all of which resolved once therapy was stopped).
Lode H, File TM, Mandell L, Ball P, Pypstra R, Thomas M. (2002). 185 Gemifloxacin Study Group. Oral gemifloxacin versus sequential therapy with intravenous ceftriaxone/oral cefuroxime with or without a macrolide in the treatment of patients hospitalized with community-acquired pneumonia: a randomized, open-label, multicenter study of clinical efficacy and tolerability. Clin Ther. (Controlled trial of oral gemifloxacin vs iv followed by oral ceftriaxone for 7-14 days in 341 patients with community acquired pneumonia; liver test elevations occurred in 7 [4.1%] gemifloxacin vs 12 [7%] ceftriaxone treated subjects, but no mention of clinically apparent liver injury).
Ball P, Mandell L, Patou G, Dankner W, Tillotson G. (2004). A new respiratory fluoroquinolone, oral gemifloxacin: a safety profile in context. Int J Antimicrob Agents. (Review of safety data from 6775 patients treated with gemifloxacin in clinical trials; frequency of adverse events was similar to that in comparator arms using other antibiotics, ALT elevations in 1.5% with gemifloxacin and 0.9% with comparators and "no significant drug-related liver reactions were observed").
Bhavnani SM, Andes DR. (2005). Gemifloxacin for the treatment of respiratory tract infections: in vitro susceptibility, pharmacokinetics and pharmacodynamics, clinical efficacy, and safety. Pharmacotherapy. (Review of pharmacokinetics, efficacy and safety of gemifloxacin; most common side effects are diarrhea, rash, nausea and headache; increased AST values occurred in 0.3% of treated patients in one study).
File TM, Mandell LA, Tillotson G, Kostov K, Georgiev O. (2007). Gemifloxacin once daily for 5 days versus 7 days for the treatment of community-acquired pneumonia: a randomized, multicentre, double-blind study. J Antimicrob Chemother. (Controlled trial comparing 5 and 7 days of oral gemifloxacin in 469 patients with community acquired pneumonia found similar rates of response and tolerance; ALT elevations occurred in 6.1% of patients, but no patient developed clinically apparent liver injury).
Lode HM, Schmidt-Ionas M, Stahlmann R. (2008). Gemifloxacin for community-acquired pneumonia. Expert Opin Investig Drugs. (Systematic review of safety and efficacy of gemifloxacin; rates of common side effects with gemifloxacin are similar to those of comparator fluoroquinolones; ALT elevations occur in 4.7-7.4% with 5 to 7 day course of oral therapy).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury but only one to a fluoroquinolone, ciprofloxacin).
Orman ES, Conjeevaram HS, Vuppalanchi R, Freston JW, Rochon J, Kleiner DE, Hayashi PH, DILIN Research Group. (2011). Clinical and histopathologic features of fluoroquinolone-induced liver injury. Clin Gastroenterol Hepatol. (Among 679 cases of drug induced liver injury presenting between 2004 and 2010 at 8 US medical centers, 12 [1.8%] were attributed to fluoroquinolones including 6 cipro-, 4 moxi-, 1 levo-, and 1 gatifloxacin; average time to onset 4 days [range 1-39], with both hepatocellular and cholestatic enzyme patterns, seven with rash or fever, mortality limited to those with hepatocellular injury and jaundice; hepatic injury appeared to be class specific; no cases were attributed to gemifloxacin).
Kilincalp S, Deveci M, Coban S, Basar O, Yuksel O. (2012). A new cause of acute hepatitis: gemifloxacin. Acta Gastroenterol Belg. (45 year old woman who was known to be HBsAg positive developed jaundice and pruritus on day 7 of a 10 day course of gemifloxacin [bilirubin 8.2 mg/dL, ALT 361 U/L, Alk P 276 U/L, HBV DNA negative], resolving within 4 weeks of stopping).
Amitabh V, Singhal A, Kumar S, Patel N, Rizvi YS, Mishra P. (2012). Efficacy and safety of oral gemifloxacin for the empirical treatment of pneumonia. Lung India. (Open label study of 105 patients with pneumonia treated with gemifloxacin for 5-7 days found no overall change in ALT, AST or Alk P levels; one patient developed elevated Alk P levels, but it was considered unrelated to the drug).
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 29 [5.1%] attributed to quinolones).
Harr T, French LE. (2012). Stevens-Johnson syndrome and toxic epidermal necrolysis. Chem Immunol Allergy. (Review of the clinical features, epidemiology, genetics and pathogenesis of SJS and TEN).
Naveen KN, Pai VV, Rai V, Athanikar SB. (2013). Retrospective analysis of Steven Johnson syndrome and toxic epidermal necrolysis over a period of 5 years from northern Karnataka, India. Indian J Pharmacol. (Among 22 patients seen at a single referral hospital in India between 2002-2007 with Stevens Johnson syndrome or toxic epidermal necrolysis, 11 were due to anticonvulsants and 7 to antibiotics, including 1 attributed to levofloxacin).
Patel TK, Barvaliya MJ, Sharma D, Tripathi C. (2013). A systematic review of the drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Indian population. Indian J Dermatol Venereol Leprol. (Systematic review of 10 case series of SJS/TEN from India identified 352 cases, among which 342 implicated a medication with most common being antimicrobials [37%], anticonvulsants [16%] and NSAIDs [16%]; fluoroquinolones accounted for 33 cases [10%], 4 of which were due to ciprofloxacin, 1 to ofloxacin and 1 to levofloxacin).
Alshammari TM, Larrat EP, Morrill HJ, Caffrey AR, Quilliam BJ, LaPlante KL. (2014). Risk of hepatotoxicity associated with fluoroquinolones: a national case-control safety study. Am J Health Syst Pharm. (Retrospective analysis of Veterans Affairs patients receiving a fluoroquinolone [n=7862] found a higher relative risk of developing acute liver injury after receipt of ciprofloxacin compared to matched controls [adjusted odds ratio: OR=1.29], but not after receipt of levofloxacin [OR=1.16) or moxifloxacin [OR=0.98]).
Arabyat RM, Raisch DW, McKoy JM, Bennett CL. (2015). Fluoroquinolone-associated tendon-rupture: a summary of reports in the Food and Drug Administration's adverse event reporting system. Expert Opin Drug Saf. (Between 2004 and 2016, 2495 instances of spontaneous tendon rupture attributed to fluoroquinolones were reported to the FDA MedWatch system, including 1555 [62%] linked to levofloxacin, 606 [24%] ciprofloxacin, 230 [9%] moxifloxacin, but only 4 [0.2%] to gemifloxacin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 US medical centers, 323 [36%] were attributed to antibiotics of which 38 were due to fluoroquinolones including 16 to ciprofloxacin, 13 levofloxacin, 8 moxifloxacin and 1 gatifloxacin, but none were attributed to gemifloxacin).
Goldberg DS, Forde KA, Carbonari DM, Lewis JD, Leidl KB, Reddy KR, Haynes K, et al. Population-representative incidence of drug-induced acute liver failure based on an analysis of an integrated health care system. Gastroenterology 2015; 148: 1353-61. e3. (Analysis of Kaiser Permanente health care database from 2004 to 2011 identified 62 patients with suspected acute liver failure, 32 [52%] of whom had a presumed drug etiology, the most common being acetaminophen [18: 56%] and various herbal products [5: 16%], with single instances attributed to imatinib, simvastatin, leflunomide, isoniazid and valproate, but none to ciprofloxacin or other fluoroquinolones).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, Ghabril MS, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss of whom 94% developed evidence of chronic liver injury suggestive of vanishing bile duct syndrome, 2 of which were due to fluoroquinolones, 1 to moxifloxacin and 1 levofloxacin).
(2018). Comparison table: some systemic fluoroquinolones. Med Lett Drugs Ther. (Table comparing 4 fluoroquinolones [cipro-, levo-, dela- and moxifloxacin] mentions that ALT and AST elevations are a class adverse event).

## OTHER REFERENCE LINKS

1 Recent References on Gemifloxacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Gemifloxacin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Gemifloxacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Gemifloxacin)